# Skullcap

## OVERVIEW

### Introduction

Skullcap is Native American plant, the dried leaves and stems of which are used as an herbal medication and in teas to treat anxiety, stress and insomnia. Skullcap has been linked to several instances of clinically apparent liver injury, but usually in combination with other botanicals.

### Background

Skullcap is a flowering perennial plant native to North America (Scutellaria lateriflora) used for centuries by Native Americans to treat menstrual disorders, nervousness, digestive and kidney problems. The name skullcap refers to the flower’s resemblance to helmets worn by European soldiers. Skullcap was used formerly for nervous disorders, including hysteria, nervous tension, epilepsy and chorea. It is now used largely as a sedative and sleeping pill, often in combination with other herbs such as valerian. Skullcap extracts are prepared from the aerial parts of the Scutellaria lateriflora plant and contain large amounts of flavonoids, including scutellarin and baicalin, which are believed to be the active components accounting for its sedative and antispasmodic activity. It is thought that the flavonoid compounds may act as gamma amino butyric acid (GABA) agonists similar to the benzodiazepines. There are more than 200 species of Scutellaria which have different components and activities as well as potential toxicities. Skullcap is available as a powder to prepare in tea, as a liquid solution and in capsules. Scutellaria is listed as a component in many commercially available, over-the-counter herbal mixtures.

### Hepatotoxicity

Skullcap has been implicated in rare instances of clinically apparent liver injury, although in most cases multiple herbal medications were being taken and the role of skullcap in the hepatic damage was unclear. Furthermore, in some instances phytochemical analysis has identified significant adulterants (germander) or mislabeling in cases of suspected skullcap hepatotoxicity. In reported cases, the onset of symptoms and jaundice occurred within 1 to 12 weeks of starting skullcap, and the serum enzyme pattern was typically hepatocellular. Immunoallergic and autoimmune features were usually absent, although low titers of autoantibodies were not infrequent. Recovery was rapid once the herbal was discontinued, but some cases have resulted in acute liver failure. Chinese skullcap is a different species, but may also have adverse effects on the liver. There have been several reports and small case series of acute liver injury with jaundice arising after 1 to 3 months of starting herbals or dietary supplements with Chinese skullcap (Scutellaria baicalensis), the liver injury resembling that associated with North American skullcap (Scutellaria lateriflora).

Likelihood score: B (very likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of skullcap hepatotoxicity is not known.

### Outcome and Management

Hepatotoxicity from skullcap is rare, and is usually mild-to-moderate in severity and resolves rapidly once the botanical is stopped. At least one case of acute liver failure has been reported with skullcap, but there have been no instances of chronic liver disease, cirrhosis or vanishing bile duct syndrome linked to skullcap administration.

Other Names: Blue pimpernel, Helmet flower, Hoodwort, Mad weed, Quaker bonnet, Scullcap, Scutellaria

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute hepatitis due to combination of skullcap and valerian.(1)

A 53 year old woman developed worsening insomnia, anxiety and jaundice 4 weeks after starting an herbal preparation for sleep that contained skullcap (Scutellaria lateriflora) and valerian root (Valeriana officianalis) for sleep. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She took no other medications except for a cup of herbal tea 2 to 3 times weekly which contained chaparral leaf (Larrea tridentate), and rare use of other miscellaneous herbals. On examination, she was jaundiced but had no fever, rash or signs of chronic liver disease. Laboratory testing showed a serum bilirubin of 9.0 mg/dL with marked increases in serum aminotransferase levels (ALT 1208 U/L, AST 1082 U/L), and modest increase in alkaline phosphatase (298 U/L) and normal prothrombin time and serum albumin (Table). The white count and differential were normal. Tests for hepatitis A, B and C were negative as were autoantibodies. Immunoglobulin levels revealed a slight increase in IgG (2240 mg/dL), but normal IgA and IgM. An anti-CMV IgM assay was positive, but urine cultures were negative and serial titers of anti-CMV were stable. Abdominal ultrasound showed no evidence of gallstones or biliary obstruction. A liver biopsy was not done. She was monitored on no therapy and improved steadily. One month later, the jaundice had resolved and 3 months after stopping the herbal, all liver tests were normal.

#### Key Points

Medication: | Skullcap and valerian (4 capsules nightly)
Pattern: | Hepatocellular (R=8.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | 12 weeks
Other medications: | None, except occasional herbal tea containing chaparral leaf

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
| | Started sleeping aid with skullcap and valerian root
4 weeks | 0 | 1208 | 298 | 9.0 | Admission, herbals stopped
8 weeks | 4 weeks | 161 | | Normal
16 weeks | 12 weeks | Normal | Normal | Normal
Normal Values | | <65 | <136 | <1.2

#### Comment

The case history is entirely compatible with drug induced liver injury caused by one of the several botanicals that she was taking. Skullcap (Scutellaria lateriflora) has been associated with cases of clinically apparent liver injury, but largely in association with other botanicals that have also been implicated in causing hepatotoxicity. Valerian has been reported to cause an acute hepatitis-like syndrome alone or in combination with skullcap, both of which have purported sedative qualities leading to their mixture in herbal preparations claimed to help sleep.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Skullcap – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Skullcap | 94279-99-9 | Herbal mixture | Not applicable

## CITED REFERENCE

1 Caldwell SH, Feeley JW, Wieboldt TF, Featherston PL, Dickson RC. (1994). Acute hepatitis with use of over-the-counter herbal remedies. Va Med Q.

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of herbals is discussed, but skullcap is not specifically mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]).
Scullcap. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 739. (Compilation of short monographs on herbal medications and dietary supplements).
Harvey J, Colin-Jones DG. (1981). Mistletoe hepatitis. Br Med J(Clin Res Ed). (49 year old woman developed fatigue and abdominal pain on two occasions after a few weeks of taking an herbal containing mistletoe and skullcap [bilirubin 2.5 mg/dL, ALT >250 U/L, Alk P 123 U/L], resolving in 6-24 weeks, the authors attributed the injury to mistletoe).
Mizoguchi Y, Miyajima K, Sakagami Y, Yamamoto S. (1986). Nippon Naika Gakkai Zasshi. (A 27 year old developed jaundice 6 weeks after taking Kinshigan, a Kampo herb with rapid recovery, but recurring with a more severe course 2 weeks after restarting [bilirubin 28.5 mg/dL, ALT 166 U/L, Alk P 1.5 times ULN, 1% eosinophils]; among 18 ingredients of the product was Scuttelariae radix).
MacGregor FB, Abernethy VE, Dahabra S, Cobden I, Hayes PC. (1989). Hepatotoxicity of herbal remedies. BMJ. (Four cases of hepatitis attributed to herbals, all women, ages 41-57, developed jaundice 2 to 8 weeks after starting herbals for stress [“Neurelax” and “Kalms”] believed to contain skullcap and/or valerian [bilirubin 13.5-28.3 mg/dL, ALT 293-1165 U/L, Alk P 97-730 U/L], resolving 2-19 months after stopping).
Miskelly FG, Goodyer LI. (1992). Hepatic and pulmonary complications of herbal medicines. Postgrad Med J. (77 year old woman developed fatigue followed by jaundice 6 months after starting an herbal product with comfrey and skullcap [bilirubin 3.5 mg/dL, AST 520 U/L, Alk P 390 U/L], resolving within 6 months of stopping).
Bruseth S, Enge A. (1992). Tidsskr Nor Laegeforen. (Letter mentioning that mistletoe has been implicated in causing liver injury, but that the patient was also taking skullcap; mistletoe has been used in more than 30,000 cancer patients with no evidence of liver injury, although allergic reactions have been reported).
Caldwell SH, Feeley JW, Wieboldt TF, Featherston PL, Dickson RC. (1994). Acute hepatitis with use of over-the-counter herbal remedies. Va Med Q. (53 year old woman developed jaundice 4 weeks after starting an herbal for sleep containing skullcap and valerian given as 4 capsules nightly [bilirubin 9 mg/dL, ALT 1208 U/L, Alk P 298 U/L, protime 13.5 sec], resolving within 3 months of stopping: Case 1).
Hullar TE, Sapers BL, Ridker PM, Jenkins RL, Huth TS, Farraye FA. (1999). Herbal toxicity and fatal hepatic failure. Am J Med. (28 year old man developed jaundice after taking skullcap and pau d’arco for 6 months for his multiple sclerosis [bilirubin 29.0 mg/dL, ALT 3917 U/L, Alk P 106 U/L, protime 20 seconds, ANA 1:640], progressing to liver failure and liver transplant 5 weeks later, dying shortly thereafter; explant showed sinusoidal obstruction syndrome).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including pyrrolizidine alkaloids, germander, celandine, chaparral, Chinese herbs and pennyroyal).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; skullcap is listed as potentially causing veno-occlusive disease).
Whiting PW, Clouston A, Kerlin P. (2002). Black cohosh and other herbal remedies associated with acute hepatitis. Med J Aust. (6 cases of severe hepatitis in patients taking herbal medications, including one on black cohosh alone and 5 taking multiple herbals including skullcap [n=3], valerian [n=2], chaparral [n=1] and greater celandine [n=1] for 1-14 weeks, presenting with jaundice [bilirubin 9.9-62.7 mg/dL, ALT 1293-3764 U/L, Alk P 80-219 U/L], 1 on black cohosh alone requiring liver transplantation, the other 5 resolving in 7-25 weeks; 3 were treated with prednisone for prolonged cholestasis).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation; mentions two reports of hepatotoxicity due to skullcap).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals: 3 Ma Huang, 3 kava, 2 LipoKinetix, 1 chaparral, 1 skullcap and 2 miscellaneous Chinese herbs).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but skullcap not mentioned as a cause).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with a review of two reports of acute liver injury attributed to skullcap in the literature).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to skullcap).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, skullcap is not listed).
Lin LZ, Harnly JM, Upton R. (2009). Comparison of the phenolic component profiles of skullcap (Scutellaria lateriflora) and germander (Teucrium canadense and T. chamaedrys), a potentially hepatotoxic adulterant. Phytochem Anal. (Herbal extracts of skullcap [S. lateriflora]) have occasionally been contaminated with germander [T. chamaedrys], but mass spectrometry can separate the two by demonstration of phenylethanoid components of germander).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; skullcap is not discussed).
Morgan SL, Baggott JE, Moreland L, Desmond R, Kendrach AC. (2009). The safety of flavocoxid, a medical food, in the dietary management of knee osteoarthritis. J Med Food. (Among 59 patients with osteoarthritis treated with flavocoxid [a medical food that contains baicalin extracted from Scutellaria baicalensis] vs placebo for 12 weeks, side effects were minor, and mean ALT or AST values did not change).
Levy R, Khokhlov A, Kopenkin S, Bart B, Ermolova T, Kantemirova R, Mazurov V, Bell M, Caldron P, Pillai L, Burnett B. (2010). Efficacy and safety of flavocoxid compared with naproxen in subjects with osteoarthritis of the knee- a subset analysis. Adv Ther. (Among 220 patients with osteoarthritis treated with flavocoxid [a medical food that contains baicalin] or naproxen for 12 weeks, rates of ALT elevations were similar and none were >5 times ULN or associated with symptoms or jaundice).
Pillai L, Burnett BP, Levy RM, GOAL Study Cooperative Group. (2010). GOAL: multicenter, open-label, post-marketing study of flavocoxid, a novel dual pathway inhibitor anti-inflammatory agent of botanical origin. Curr Med Res Opin. (Among 1005 patients with osteoarthritis treated with flavocoxid [a medical food that contains baicalin] in an open label study, only one subject had liver test abnormalities, but no details given).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to skullcap).
Linnebur SA, Rapacchietta OC, Vejar M. Hepatotoxicity associated with Chinese skullcap contained in Move Free Advanced dietary supplement: two case reports and review of the literature. Pharmacotherapy 2010; 3(7): 750, 258e-262e. (Two patients developed liver injury within weeks of taking “Move Free Advanced”, which contains Chinese skullcap [Scutellaria baicalensis] for arthralgias, resolving upon stopping).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon herbalife and hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; skullcap is not discussed).
Yang L, Aronsohn A, Hart J, Jensen D. (2012). Herbal hepatoxicity from Chinese skullcap: A case report. World J Hepatol. (78 year old woman developed jaundice 3 weeks after starting an herbal mixture of glucosamine, chondroitin, black catechu and Chinese skullcap [Scutellaria baicalensis] [bilirubin 7.2 mg/dL, ALT 1626 U/L, Alk P 354 U/L], resolving on stopping and recurring within 2 weeks of restarting).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Among 9360 drug adverse reports made during 2007 and 2008 to a Korean pharmacovigilance center, 567 were hepatic of which only 3 were due to herbal medications, specific ingredients of which were not given).
Chalasani N, Vuppalanchi R, Navarro V, Fontana R, Bonkovsky H, Barnhart H, Kleiner DE, et al. (2012). Acute liver injury due to flavocoxid (Limbrel), a medical food for osteoarthritis: a case series. Ann Intern Med. (Flavocoxid, a medical food that contains Scutelleria baicalensis and Acacia catechu, was implicated in 4 cases of clinically apparent liver injury in women, ages 57 to 68 years, arising within 1-3 months of starting [bilirubin 2.0-20.8 mg/dL, ALT 741-1540 U/L, Alk P 286-770 U/L], resolving within 1-3 months of stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including 4 reports that mention skullcap: MacGregor [1989], Calwell [1994], Hullar [1999], Estes [2003]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Review of literature on hepatotoxicity due to herbals and dietary supplements; skullcap is mentioned, but not specifically discussed).
Dhanasekaran R, Owens V, Sanchez W. (2013). Chinese skullcap in move free arthritis supplement causes drug induced liver injury and pulmonary infiltrates. Case Reports Hepatol. (62 year old woman developed pneumonitis and jaundice 2-3 weeks after starting Move Free, a supplement that contained glucosamine, chondroitin, MSM, skullcap and black catechu [bilirubin 2.9 rising to 6.9 mg/dL, ALT 700 U/L, Alk P 250 U/L], worsening for 2 weeks and then resolving 4-8 weeks after stopping).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which were attributed to skullcap).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among 2 cases attributed to skullcap, the response to reexposure was scored as negative).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, skullcap was not specifically implicated in any case).
Woo HJ, Kim HY, Choi ES, Cho YH, Kim Y, Lee JH, Jang E. (2015). Drug-induced liver injury: A 2-year retrospective study of 1169 hospitalized patients in a single medical center. Phytomedicine. (Over a 2.5 year period and among 1169 hospitalized patients at a Korean medical center, 3 cases of liver injury possibly due to Scutellariae Radix were identified, all 3 hepatocellular arising after 33-48 days).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver lists skullcap as a potential cause of cholestasis and acute liver failure).
Papafragkakis C, Ona MA, Reddy M, Anand S. (2016). Acute hepatitis after ingestion of a preparation of Chinese skullcap and black catechu for joint pain. Case Reports Hepatol. (54 year old woman developed pruritus, diarrhea and jaundice 2-4 weeks after starting skullcap and black catechu for joint pains [bilirubin 12.8 mg/dL, ALT 2312 U/L, Alk P 285 U/L, INR 1.0], resolving upon stopping the supplement).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list or discuss skullcap).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, 2 reports of liver injury attributed to Scutellaria lateriflora [Estes 2003][Hullar 1999]).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, but specific ingredients were not listed; skullcap is mentioned as a cause of acute liver failure as documented in the literature [Estes 2003]).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, Chinese skullcap, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient nutrition supplements [MINS]).
Shimada Y, Fujimoto M, Nogami T, Watari H, Kitahara H, Misawa H, Kimbara Y, Kita KI. (2018). Recurrent drug-induced liver injury caused by the incidental readministration of a Kampo Formula containing Scutellariae radix. Intern Med. (67 year old woman had two episodes of liver injury having received different Kampo herbal regimens both of which contained Scuttellariae radix [bilirubin 1.1 and 1.3 mg/dL, ALT 139 and 880 U/L and Alk P 362 and 691 U/L], resolving rapidly each time upon stopping the herbal mixtures).
Wang ZL, Wang S, Kuang Y, Hu ZM, Qiao X, Ye M. (2018). A comprehensive review on phytochemistry, pharmacology, and flavonoid biosynthesis of Scutellaria baicalensis. Pharm Biol. (Extensive review of the chemical composition, in vitro activities of Scutellaria baicalensis with discussion of the in vitro and in vivo evidence for its potential antibacterial, antiviral, antiinflammatory, antitumor, antioxidant and hepato- and neuro-protective activities; no discussion of toxicities).
Braude MR, Bassily R. (2019). Drug-induced liver injury secondary to Scutellaria baicalensis (Chinese skullcap). Intern Med J. (51 year old man developed abdominal pain followed by jaundice 10 days after starting a herbal supplement that contained Scutellariae baicalensis [400 mg] [bilirubin 2.6 rising to 24.0 mg/dL, ALT 147 U/L, Alk P 147 U/L, INR 1.0], worsening for 3 weeks but then resolving within 12 weeks of stopping).
Puri BK, White N, Monro JA. (2019). The effect of supplementation with Scutellaria baicalensis on hepatic function. Med Hypotheses. (The authors review the literature on hepatotoxicity of Scutellaria baicalensis [Chinese skullcap] and conclude that there is no convincing evidence that it causes liver injury).
Zhao T, Tang H, Xie L, Zheng Y, Ma Z, Sun Q, Li X. (2019). Scutellaria baicalensis Georgi. (Lamiaceae): a review of its traditional uses, botany, phytochemistry, pharmacology and toxicology. J Pharm Pharmacol. (Review of the chemistry, clinical uses and toxicity of Scutellaria Baicalensis, a major ingredient in many traditional Chinese medicines, which contains more than 40 compounds including flavonoids [baicalin, mogonin], terpenoids, volatile acids and polysaccharides, used for liver protection, and treatment of diarrhea, vomiting, and high blood pressure, known as Huang Qin [yellow reed]; “there is no obvious adverse reaction in the oral preparation of Scutellaria baicalensis”, but it may cause stomach discomfort, diarrhea and other minor symptoms in some patients).

## OTHER REFERENCE LINKS

1 Recent References on Skullcap: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Skullcap+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Skullcap: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Skullcap)